# Ruxolitinib

## OVERVIEW

### Introduction

Ruxolitinib is a small molecule Janus kinase inhibitor that is used in the treatment of intermediate or high risk myelofibrosis and resistant forms of polycythemia vera and graft-vs-host disease. Ruxolitinib is associated with transient and usually mild elevations in serum aminotransferase during therapy and to rare instances of self-limited, clinically apparent idiosyncratic acute liver injury as well as to cases of reactivation of hepatitis B in susceptible individuals.

### Background

Ruxolitinib (rux” oh li’ ti nib) is an orally available, specific inhibitor of Janus kinase subtypes 1 and 2 (JAK1 and JAK2). JAK1 and JAK2 are non-receptor tyrosine kinases that are critical components of pathways that lead to production and secretion of hematologic growth factors and inflammatory cytokines. These pathways are important in hematologic cell differentiation and proliferation, intracellular signaling by interferon alpha and gamma, and in cytokine-production and inflammatory reactions. Mutations in JAK1 and JAK2 are frequent in patients with myelofibrosis, and inhibition of these kinases can result in antiproliferative and antiapoptotic effects in malignant cells. Ruxolitinib has been shown to improve symptoms, cause shrinkage of spleen size and decrease circulating cytokine levels in patients with myelofibrosis and polycythemia vera independent of the known presence of Janus kinase mutations. It has also been shown to be effective in both acute and chronic graft-vs-host disease. Ruxolitinib was approved for use in the United States in 2011 for therapy of intermediate and high risk myelofibrosis. Subsequently, indications were extended to include polycythemia vera resistant or intolerant to conventional therapy as well as corticosteroid-resistant acute and refractory chronic graft-vs-host disease. Ruxolitinib is currently available in tablets of 5, 10, 15, 20 and 25 mg under the brand name Jakafi. Typical doses of ruxolitinib range from 5 to 20 mg given orally twice daily. The recommended dose varies by indication and clinical status including platelet count and tolerance. Dose adjustments for liver or kidney dysfunction and for possible drug-drug interactions are also recommended. Common side effects include myelosuppression, anemia, thrombocytopenia, fatigue, diarrhea, bruising, dizziness, dyspnea, headache and peripheral edema. Sudden withdrawal of ruxolitinib is associated with rapid relapse of symptoms which can be severe with fever, respiratory distress, anemia and features of the systemic inflammatory response syndrome. Uncommon but potentially severe adverse reactions include reactivation of tuberculosis, hepatitis B and herpes zoster as well as severe thrombocytopenia, neutropenia and anemia, opportunistic infections, fetal and embryonal toxicity, and progressive multifocal leukoencephalopathy.

More recently, ruxolitinib has been evaluated as therapy for the hyperinflammatory state associated with SARS-CoV-2 infection and severe COVID-19 pneumonia. Results of these studies have not been released and only anecdotal reports of its use in patients with COVID-19 have been published.

### Hepatotoxicity

In the large clinical trials, serum ALT elevations occurred in 25% to 48% of ruxolitinib treated subjects versus 7% to 9% of placebo recipients. The ALT elevations were generally self-limited, asymptomatic and mild and were above 5 times ULN in only 1.3% of patients. In the prelicensure clinical trials, no cases of clinically apparent liver injury were reported. Among causes of death in one trial of ruxolitinib for myelofibrosis, one was attributed to hepatic failure; this instance, however, was considered unrelated to ruxolitinib. Since its approval and more wide scale use, rare cases of clinically apparent ruxolitinib induced acute liver injury have been reported, but without documentation of clinical features or careful exclusion of other causes. Importantly, there also have been several published reports of reactivation of hepatitis B, in patients with and without HBsAg (but with anti-HBc) in serum. A rise in HBV DNA levels was identified within 1 to 6 months of starting ruxolitinib and was associated with elevations in ALT levels and jaundice in some patients. HBV DNA levels decreased rapidly upon starting anti-HBV therapy with entecavir and all patients recovered. In one instance, HBV DNA levels declined with lowering of the dose of ruxolitinib, but then rose again when the dose was increased.

So far, reports of the use of ruxolitinib for COVID-19 have included only small numbers of patients and have provided little information on hepatic adverse events or risk of reactivation of hepatitis B.

Likelihood score: C (probable cause of reactivation of hepatitis B in susceptible patients).

### Mechanism of Injury

The causes of serum enzyme elevations during ruxolitinib therapy are not known. Ruxolitinib is metabolized in the liver largely through the CYP 3A4 pathway and liver injury may be related to production of a toxic intermediate. Ruxolitinib is susceptible to drug-drug interactions with agents that inhibit or induce hepatic CYP 3A4 activity. Because of its effects on intracellular signaling involved in immune responses, ruxolitinib (and possibly other JAK1 and JAK2 inhibitors) is capable to increasing HBV replication which can result in clinically apparent reactivation of hepatitis B.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) or any elevations accompanied by jaundice or symptoms should lead to dose reduction or temporary cessation. There does not appear to be cross reactivity in risk for hepatic injury between ruxolitinib and other kinase inhibitors. Ruxolitinib is capable of causing reactivation of hepatitis B and other opportunistic infections and patients should be screened for evidence of HBV infection before starting chemotherapy, including testing for HBsAg and anti-HBc. Those who are reactive for these virologic markers should be tested for serum HBV DNA and be considered for prophylaxis against HBV reactivation with a nucleoside analog such as tenofovir or entecavir particularly if they are HBsAg-positive. Reactivation of hepatitis B with ruxolitinib therapy is rare in patients with anti-HBc without HBsAg in serum and such patients can be monitored for HBV DNA levels and therapy initiated with a significant rise (one or two log_10_ IU/mL compared to baseline).

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors, COVID-19 Drugs

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ruxolitinib – Jakafi®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Ruxolitinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Ruxolitinib | 941678-49-5 | C17-H18-N6

## ANNOTATED BIBLIOGRAPHY

References updated: 30 August 2022

Abbreviations: EAP, early access programs; EUA, emergency use authorization; GvHD, graft-vs-host disease; HCT, hematopoietic cell transplantation; JAK, Janus kinase.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase inhibitors such as ruxolitinib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not ruxolitinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
Verstovsek S, Kantarjian H, Mesa RA, Pardanani AD, Cortes-Franco J, Thomas DA, Estrov Z, et al. (2010). Safety and efficacy of INCB018424, a JAK1 and JAK2 inhibitor, in myelofibrosis. N Engl J Med. (Among 153 patients with myelofibrosis treated with varying doses of ruxolitinib, the optimal regimen was 15 mg twice daily, with subsequent dose modifications, a regimen that yielded a 50% rapid, objective response regardless of JAK mutation status; side effects included dose related thrombocytopenia and anemia while nonhematologic side effects were uncommon [<6%] and included diarrhea, fatigue, headache, and peripheral edema; no mention of ALT elevations of hepatotoxicity).
Tefferi A, Pardanani A. (2011). Serious adverse events during ruxolitinib treatment discontinuation in patients with myelofibrosis. Mayo Clin Proc. (Among 47 patients with myelofibrosis who discontinued ruxolitinib treatment, most patients had an acute relapse of symptoms within a few days or weeks of stopping and 5 required hospitalization because of suspected systemic inflammatory response syndrome with high fevers, respiratory distress, thromboses and anemia, often responding to corticosteroid therapy).
Verstovsek S, Mesa RA, Gotlib J, Levy RS, Gupta V, DiPersio JF, Catalano JV, et al. (2012). A double-blind, placebo-controlled trial of ruxolitinib for myelofibrosis. N Engl J Med. (In a study of 309 patients with intermediate or high risk myelofibrosis treated for up to 1 year, objective responses [reduction in spleen volume] occurred in 42% of ruxolitinib, but <1% of placebo treated subjects; adverse events more common with ruxolitinib included thrombocytopenia [70% vs 30%], anemia [96% vs 87%], bruising [19% vs 9%] and dizziness [15% vs <1%]; no mention of ALT elevations or hepatotoxicity).
(2012). Ruxolitinib (Jakafi) for myelofibrosis. Med Lett Drugs Ther. (Concise review of efficacy and safety of ruxolitinib as therapy for myelofibrosis, mentions severe withdrawal symptoms when the drug is stopped that may require corticosteroids).
Harrison C, Kiladjian JJ, Al-Ali HK, Gisslinger H, Waltzman R, Stalbovskaya V, McQuitty M, et al. (2012). JAK inhibition with ruxolitinib versus best available therapy for myelofibrosis. N Engl J Med. (Among 219 patients with intermediate or high risk myelofibrosis treated with ruxolitinib or best available therapy for at least one year, improvement in clinical symptoms and shrinkage of spleen size occurred with ruxolitinib, but rarely without; listing of severe adverse events included one death from hepatic failure, but it was considered unrelated to ruxolitinib therapy).
Verstovsek S, Mesa RA, Gotlib J, Levy RS, Gupta V, DiPersio JF, Catalano JV, et al. (2013). Efficacy, safety and survival with ruxolitinib in patients with myelofibrosis: results of a median 2-year follow-up of COMFORT-I. Haematologica. (Among 155 patients with myelofibrosis treated with ruxolitinib, 100 continued on therapy with a median follow up of 2 years; most common side effects were dose related thrombocytopenia and anemia and nonhematologic side effects of bruising, headache and diarrhea; no mention of hepatotoxicity or ALT elevations).
Kantarjian HM, Silver RT, Komrokji RS, Mesa RA, Tacke R, Harrison CN. (2013). Ruxolitinib for myelofibrosis--an update of its clinical effects. Clin Lymphoma Myeloma Leuk. (Review of the efficacy and safety of ruxolitinib as therapy of myelofibrosis, the major severe side effects being hematologic; no discussion of hepatotoxicity or ALT elevations).
Spraggs CF, Xu CF, Hunt CM. (2013). Genetic characterization to improve interpretation and clinical management of hepatotoxicity caused by tyrosine kinase inhibitors. Pharmacogenomics. (Review of genetic associations of serum ALT and bilirubin elevations during therapy with tyrosine kinase inhibitors focusing on lapatinib and pazopanib).
Shah RR, Morganroth J, Shah DR. (2013). Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013; aminotransferase elevations occurred in 18% of patients in registration trials of ruxolitinib, but were rarely above 5 times ULN and cases of clinically apparent liver injury have not been reported).
Cervantes F, Vannucchi AM, Kiladjian JJ, Al-Ali HK, Sirulnik A, Stalbovskaya V, McQuitty M, et al., COMFORT-II investigators. (2013). Three-year efficacy, safety, and survival findings from COMFORT-II, a phase 3 study comparing ruxolitinib with best available therapy for myelofibrosis. Blood. (In a 3 year open label extension of a trial of ruxolitinib versus placebo in patients with myelofibrosis [Harrison 2012], 106 patients remained on ruxolitinib for an average of 3 years, responses were maintained with continuation of therapy and adverse events were mostly mild, the most common being diarrhea; no mention of ALT elevations or hepatotoxicity).
Verstovsek S, Passamonti F, Rambaldi A, Barosi G, Rosen PJ, Rumi E, Gattoni E, et al. (2014). A phase 2 study of ruxolitinib, an oral JAK1 and JAK2 Inhibitor, in patients with advanced polycythemia vera who are refractory or intolerant to hydroxyurea. Cancer. (Among 34 patients with polycythemia vera treated with ruxolitinib, 97% had an objective response and side effects were not common and generally mild; no mention of ALT elevations or hepatotoxicity).
Galli S, McLornan D, Harrison C. (2014). Safety evaluation of ruxolitinib for treating myelofibrosis. Expert Opin Drug Saf. (Review of the mode of action, pharmacology, clinical efficacy and safety of ruxolitinib does not discuss frequency of ALT elevations during therapy or clinically apparent hepatotoxicity).
Caocci G, Murgia F, Podda L, Solinas A, Atzeni S, La Nasa G. (2014). Reactivation of hepatitis B virus infection following ruxolitinib treatment in a patient with myelofibrosis. Leukemia. (49 year old woman with thrombocytopenic myelofibrosis and HBsAg in serum [HBeAg and HBV DNA <10 IU/mL] developed rising levels of HBV DNA within 5 months of starting ruxolitinib [20 mg twice daily], decreasing with lowering dose [15 mg twice daily] and increasing again with full dose, but without liver test abnormalities [ALT normal, HBV DNA 38,300 IU/mL] and HBV DNA levels declining with lowering dose again).
Shen CH, Hwang CE, Chen YY, Chen CC. (2014). Hepatitis B virus reactivation associated with ruxolitinib. Ann Hematol. (72 year old man with essential thrombocythemia and HBsAg in serum [ALT 22 U/L] developed abnormal liver tests 8 months after starting ruxolitinib [peak bilirubin 1.8 mg/dL, ALT 291 U/L, HBV DNA 7 log10 copies/mL], resolving within 8 weeks of stopping ruxolitinib and 6 weeks of starting entecavir).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 were attributed to antineoplastic agents [5.5%], 3 of which were attributed to kinase inhibitors [imatinib, lapatinib], but none to ruxolitinib).
Kirito K, Sakamoto M, Enomoto N. (2016). Elevation of the hepatitis B virus DNA during the treatment of polycythemia vera with the JAK kinase inhibitor ruxolitinib. Intern Med. (64 year old woman with polycythemia vera [ALT normal, HBeAg negative, HBV DNA 5.4 log_10_ copies/mL] developed liver test abnormalities 1 month after starting ruxolitinib [bilirubin normal, ALT 352 U/L, HBV DNA 7.2 log_10_ copies/mL], responding within 2 weeks of starting entecavir with normal ALT and HBV DNA 3.6 log_10_ copies/mL).
Perricone G, Vinci M, Pungolino E. (2017). Occult hepatitis B infection reactivation after ruxolitinib therapy. Dig Liver Dis. (Two men, ages 57 and 73 years, with polycythemia vera and anti-HBc without HBsAg in serum developed increasing levels of HBV DNA [from 39 to 840 IU/mL and <10 to 42.2 million IU/mL] 2 and 5 months after starting ruxolitinib, both responding to entecavir therapy, but one developing self-limited, but severe acute hepatitis).
Tremblay D, Putra J, Vogel A, Winters A, Hoffman R, Schiano TD, Fiel MI, et al. (2019). The implications of liver biopsy results in patients with myeloproliferative neoplasms being treated with ruxolitinib. Case Rep Hematol. (Description of 4 cases of liver injury associated with ruxolitinib therapy, 49 to 74 year old men with rising ALT or Alk P during therapy and liver biopsies showing extramedullary hematopoiesis attributed to the underlying myelofibrosis in 3 and granulomatous hepatitis with loss of bile ducts attributed to drug induced liver injury in one, but few details given).
Foltz L, Pica GM, Zerazhi H, Van Droogenbroeck J, Visanica S, Báez de la Fuente E, Leber B, et al. (2019). Safety and efficacy findings from the open-label, multicenter, phase 3b, expanded treatment protocol study of ruxolitinib for treatment of patients with polycythemia vera who are resistant/intolerant to hydroxyurea and for whom no alternative treatments are available. Leuk Lymphoma. (Among 161 patients with polycythemia vera enrolled in an expanded access study of ruxolitinib for a median follow up of 25 weeks, adverse events were common and led to dose interruption or reduction in 40% of patients, most common adverse events being anemia [32%], thrombocytopenia [7%], headache [25%], diarrhea [14%]; no mention of ALT elevations or hepatotoxicity).
Lussana F, Cattaneo M, Rambaldi A, Squizzato A. (2018). Ruxolitinib-associated infections: a systematic review and meta-analysis. Am J Hematol. (Systematic review of the literature on infections arising during ruxolitinib therapy focusing largely on bacterial infections and herpes zoster, mentions that there have been 5 case reports of reactivation of hepatitis B).
Gill H, Leung GMK, Seto WK, Kwong YL. (2019). Risk of viral reactivation in patients with occult hepatitis B virus infection during ruxolitinib treatment. Ann Hematol. (Among 40 Chinese patients with myelodysplastic disorders treated with ruxolitinib, 3 were HBsAg positive and were given prophylactic entecavir, and 17 had anti-HBc without HBsAg in serum and were monitored closely 4 developing evidence of reactivation with de novo appearance of HBV DNA after 7-13 months of being treated, all were started on entecavir within 8-35 days and HBV DNA was cleared within 4 weeks, 2 subjects having mild, transient ALT elevations).
Jianguo L, Zhixuan Z, Rong L, Xiaodong S. (2020). Ruxolitinib in alleviating the cytokine storm of hemophagocytic lymphohistiocytosis. Pediatrics. (6 year old boy with idiopathic hemophagocytic lymphohistiocytic and chronic hepatitis B was treated with ruxolitinib and entecavir and had a sustained remission and improvement in serum HBV DNA and no worsening of ALT levels).
Kiladjian JJ, Zachee P, Hino M, Pane F, Masszi T, Harrison CN, Mesa R, et al. (2020). Long-term efficacy and safety of ruxolitinib versus best available therapy in polycythaemia vera (RESPONSE): 5-year follow up of a phase 3 study. Lancet Haematol. (Among 222 patients with polycythemia vera treated with ruxolitinib or best available therapy for at least 80 weeks with cross over to ruxolitinib and continuation for 5 years in 65% of patients, durable response rates were seen only with ruxolitinib therapy and side effects were common but there were no treatment- or liver related deaths and no mention of ALT elevations or hepatotoxicity).
Al-Ali HK, Griesshammer M, Foltz L, Palumbo GA, Martino B, Palandri F, Liberati AM, et al. (2020). Primary analysis of JUMP, a phase 3b, expanded-access study evaluating the safety and efficacy of ruxolitinib in patients with myelofibrosis, including those with low platelet counts. Br J Haematol. (Among 2233 patients with myelofibrosis treated in an expanded access study of ruxolitinib with a median duration of exposure of 12.4 months, ALT elevations were reported in 6% of patients and were above 5 times the ULN in 1.1%).
Jagasia M, Perales MA, Schroeder MA, Ali H, Shah NN, Chen YB, Fazal S, et al. (2020). Ruxolitinib for the treatment of steroid-refractory acute GVHD (REACH1): a multicenter, open-label phase 2 trial. Blood. (Among 71 patients with corticosteroid-resistant GvHD treated with ruxolitinib, the overall response rate by day 28 was 55% and ultimately in 73% while adverse events were common [97%] including anemia, thrombocytopenia and neutropenia, often leading to drug discontinuation [32%], while ALT elevations arose in 18 [25%] and were above 5 times ULN in 4 subjects [6%]).
Zeiser R, von Bubnoff N, Butler J, Mohty M, Niederwieser D, Or R, Szer J, et al., REACH2 Trial Group. (2020). Ruxolitinib for glucocorticoid-refractory acute graft-versus-host disease. N Engl J Med. (Among 309 patients with acute steroid-resistant GvHD treated with ruxolitinib or placebo for an average of 63 days, overall response rates were higher with ruxolitinib while adverse event rates were similar including any ALT elevation [7% vs 7%] and elevations above 5 times ULN [4% vs 3%] and there were no instances of clinically apparent liver injury).
Zhao Y, Wu H, Shi J, Luo Y, Li X, Lan J, Ni W, et al. (2020). Ruxolitinib combined with etanercept induce a rapid response to corticosteroid-refractory severe acute graft vs host disease after allogeneic stem cell transplantation: Results of a multi-center prospective study. Am J Hematol. (Among 64 patients with acute, corticosteroid-resistant GvHD after HCT who were treated with the combination of etanercept and ruxolitinib, the response rate was 88% and while infectious adverse events were common, there was no mention of ALT elevations or hepatotoxicity).
Barraco F, Greil R, Herbrecht R, Schmidt B, Reiter A, Willenbacher W, Raymakers R, et al. (2020). Real-world non-interventional long-term post-authorisation safety study of ruxolitinib in myelofibrosis. Br J Haematol. (Among 426 patients with myelofibrosis with an average follow up of 26 months, those treated with ruxolitinib [n=259] compared to non-exposed patients [n=167] were more likely to have serious adverse events [65% to 80% vs 43%] including severe infections [49-68% vs 27.5%] and bleeding [31-41% vs 22%] and malignancies [14-27% vs 7%), but ALT and hepatotoxicity were not mentioned).
Hou C, Dou L, Jia M, Li F, Wang S, Gao X, Wang L, Jin X, Wang L, Gao C, Liu D. (2021). Ruxolitinib combined with corticosteroids as first-line therapy for acute graft-versus-host disease in haploidentical peripheral blood stem cell transplantation recipients. Transplant Cell Ther. (Among 32 patients with acute GvHD after HCT treated with methylprednisolone and ruxolitinib, response rate at 6 months was 97% and “no hepatotoxicity was observed”).
Cao Y, Wei J, Zou L, Jiang T, Wang G, Chen L, Huang L, et al. (2020). Ruxolitinib in treatment of severe coronavirus disease 2019 (COVID-19): A multicenter, single-blind, randomized controlled trial. J Allergy Clin Immunol. (Among 41 adults with severe COVID-19 pneumonia treated with ruxolitinib [5 mg twice daily] or placebo, time to recovery [12 vs 15 days] and mortality [0% vs 14.5%] were lower numerically but not significantly with ruxolitinib and serum ALT elevations arose in 35% vs 9.5%, although all elevations were less than 5 times ULN and no patient had clinically apparent liver injury attributable to treatment).
Giudice V, Pagliano P, Vatrella A, Masullo A, Poto S, Polverino BM, Gammaldi R, et al. (2020). Combination of ruxolitinib and eculizumab for treatment of severe SARS-CoV-2-related acute respiratory distress syndrome: a controlled study. Front Pharmacol. (Among 17 adults with moderate-to-severe COVID-19 pneumonia, 7 who were treated with ruxolitinib and eculizumab were compared to 10 with standard care, demonstrating more rapid recovery of oxygenation levels in the treatment group, but similar rates of death [14% vs 10%] and ALT elevations [57% vs 40%]).
La Rosée F, Bremer HC, Gehrke I, Kehr A, Hochhaus A, Birndt S, Fellhauer M, et al. (2020). The Janus kinase 1/2 inhibitor ruxolitinib in COVID-19 with severe systemic hyperinflammation. Leukemia. (Among 14 patients with severe COVID-19 and evidence of hyperinflammation who were treated with ruxolitinib for up to 14 days, 10 had rapid improvement and recovery and one died; mean ALT levels increased on therapy [from 50 to 109 U/L] rising above 5 times ULN in one subject).
Neubauer A, Wiesmann T, Vogelmeier CF, Mack E, Skevaki C, Gaik C, Keller C, et al. (2020). Ruxolitinib for the treatment of SARS-CoV-2 induced acute respiratory distress syndrome (ARDS). Leukemia. (Letter reporting case of a 65 year old Asian woman with severe COVID-19 pneumonia requiring mechanical ventilation who was treated with ruxolitinib and had rapid decrease in inflammatory markers in serum and subsequent clinical improvement).
Saraceni F, Scortechini I, Mancini G, Mariani M, Federici I, Gaetani M, Barbatelli P, et al. (2021). Severe COVID-19 in a patient with chronic graft-versus-host disease after hematopoietic stem cell transplant successfully treated with ruxolitinib. Transpl Infect Dis. (59 year old man with myelofibrosis and hematopoietic cell transplant on ruxolitinib developed COVID-19 and respiratory failure with temporary discontinuation of ruxolitinib, but marked improvement when it was restarted with “no significant alteration of other laboratory tests” suggesting that it is not only safe but may be beneficial for SARS-CoV-2 infection).
Innes AJ, Cook LB, Marks S, Bataillard E, Crossette-Thambiah C, Sivasubramaniam G, Apperley J, et al. (2020). Ruxolitinib for tocilizumab-refractory severe COVID-19 infection. Br J Haematol. (53 year old man with hematopoietic cell transplant on immunosuppressive agents developed COVID-19 pneumonia with a progressive downhill course that reversed soon after ruxolitinib [10 mg twice daily] was started] and “liver function” remained stable).
Capochiani E, Frediani B, Iervasi G, Paolicchi A, Sani S, Roncucci P, Cuccaro A, et al. (2020). Ruxolitinib rapidly reduces acute respiratory distress syndrome in COVID-19 disease. analysis of data collection from RESPIRE Protocol. Front Med (Lausanne). (Among 18 patients with severe and progressive COVID-19 pneumonia treated with ruxolitinib [20 mg twice daily initially] there was rapid improvement in 16 patients; no mention of hepatic adverse events).
Vannucchi AM, Sordi B, Morettini A, Nozzoli C, Poggesi L, Pieralli F, Bartoloni A, et al., RUXO-COVID Study Group. (2021). Compassionate use of JAK1/2 inhibitor ruxolitinib for severe COVID-19: a prospective observational study. Leukemia. (Among 34 patients with severe COVID-19 pneumonia treated with ruxolitinib [5-10 mg bid] for an average of 13 days, 84% had clinical improvement by day 28, 3 had prolonged illness, and 2 died; ALT elevations were present in 29% at baseline and arose de novo in 15%, but none were above 5 times ULN).
Gozzetti A, Capochiani E, Bocchia M. (2020). The Janus kinase 1/2 inhibitor ruxolitinib in COVID-19. Leukemia. (Letter in response to mentioning their study [Capochiani] in which a higher dose of ruxolitinib was used [20 mg bid deescalating to 5 mg bid for a total of 14 days]).
Sammartano V, Santoni A, Frediani B, Sicuranza A, Emanuele C, Franchi F, Capochiani E, et al. (2020). Efficacy and safety of ruxolitinib for Covid-19 related acute respiratory distress syndrome in a patient with blastic plasmacytoid dendritic cell neoplasm (leukemic variant). Leuk Lymphoma. (Case of 59 year old man with blastic plasmacytoid dendritic cell neoplasm on chemotherapy developed COVID-19 related respiratory failure and failed to respond to standard care, corticosteroids and tocilizumab, demonstrated clinical improvement within days of starting ruxolitinib [20 mg twice daily]; no mention of hepatic adverse events).
Betelli M, De Stefano F, Tedeschi A. (2020). Late worsening of COVID-19 pneumonia: successful treatment with ruxolitinib and steroid. Eur J Case Rep Intern Med. (Case report of 67 year old man with COVID-19 pneumonia who had a recurrence of symptoms and signs a week after recovery but without detectable SARS-CoV-2 positivity responding to antibiotics, dexamethasone and ruxolitinib; no mention of liver test abnormalities).
Caradec E, Mouren D, Zrounba M, Azoulay LD, Blandin C, Ivanoff S, Levy V, et al. (2021). COVID-19 in a patient with idiopathic pulmonary fibrosis successfully treated with ruxolitinib. Respir Med Res. (69 year old man with idiopathic pulmonary fibrosis and COVID-19 pneumonia with progressive pulmonary dysfunction was treated with ruxolitinib [10 mg twice daily] and had rapid improvement in lung function and was discharged without supplement oxygen 2 weeks later).
Peterson D, Damsky W, King B. (2020). The use of Janus kinase inhibitors in the time of severe acute respiratory syndrome coronavirus 2 (SARS-CoV-2). J Am Acad Dermatol. (Letter expressing caution about use of Janus kinase inhibitors during COVID-19 infection based upon their mechanism of action in blocking intracellular signaling pathways mediated by Janus kinases, but also mentioning 3 patients with alopecia areata who developed COVID-19 infection while on an inhibitor and had a relative mild, normal course of infection).
Satarker S, Tom AA, Shaji RA, Alosious A, Luvis M, Nampoothiri M. (2021). JAK-STAT pathway inhibition and their implications in COVID-19 therapy. Postgrad Med. (Review of the mechanism of action and pleomorphic activities of Janus kinase inhibitors and their possible role in treating severe COVID-19 infection which is often accompanied by high levels of proinflammatory cytokines [cytokine storm], with listing of ongoing trials including several of ruxolitinib).
Wong HS, Guo CL, Lin GH, Lee KY, Okada Y, Chang WC. (2021). Transcriptome network analyses in human coronavirus infections suggest a rational use of immunomodulatory drugs for COVID-19 therapy. Genomics. (Analysis of the temporal pattern of gene expression in cells infected with SARS-CoV-2 suggests that medications most likely to affect these changes include among others dexamethasone, baricitinib, tofacitinib, sarilumab, ritonavir, naproxen, avelumab, durvalumab and atezolizumab).
Banerjee A, Goswami RP, Chatterjee M. (2021). Network theoretic analysis of JAK/STAT pathway and extrapolation to drugs and viruses including COVID-19. Sci Rep. (A theoretic analysis of the pathways affected by various rheumatologic medications and pathways affected by viral infections suggests that baricitinib would have the highest likelihood of efficacy in SARS-CoV-2 infection with lower efficacy of the other Janus kinase inhibitors, tofacitinib and ruxolitinib).
D'Alessio A, Del Poggio P, Bracchi F, Cesana G, Sertori N, Di Mauro D, Fargnoli A, et al. (2021). Low-dose ruxolitinib plus steroid in severe SARS-CoV-2 pneumonia. Leukemia. (Among 32 patients with severe COVID-19 pneumonia treated with ruxolitinib [5 mg twice daily for 7 and once daily for 3 days], recovery without ICU admission was higher than in an untreated control group [75% vs 63%] and mortality was less [9% vs 30%), and they “did not observe any major adverse events”).
Rizk JG, Forthal DN, Kalantar-Zadeh K, Mehra MR, Lavie CJ, Rizk Y, Pfeiffer JP, et al. (2021). Expanded Access Programs, compassionate drug use, and Emergency Use Authorizations during the COVID-19 pandemic. Drug Discov Today. (Review of expanded access programs [EAP] and emergency use authorization [EUA] for COVID-19 interventions by the FDA during 2020 mentions that both baricitinib and ruxolitinib were allowed EAPs, but only baricitinib was granted an EUA).
Mortara A, Mazzetti S, Margonato D, Delfino P, Bersano C, Catagnano F, Lauriola M, et al. (2021). Compassionate use of ruxolitinib in patients with SARS-Cov-2 infection not on mechanical ventilation: Short-term effects on inflammation and ventilation. Clin Transl Sci. (Among 31 patients hospitalized with severe COVID-19 pneumonia and hypoxemia treated with ruxolitinib [5 mg twice daily for up to 15 days], symptomatic improvement occurred by 7 days in 81%, “no adverse events were recorded” and there were no significant changes in laboratory test results).
Raghuvanshi R, Bharate SB. (2022). Recent developments in the use of kinase inhibitors for management of viral infections. J Med Chem. (Review of the kinase inhibitors approved for use in the US, their mechanisms of action and possible role in inhibiting viral replication).
Iastrebner M, Castro J, García Espina E, Lettieri C, Payaslian S, Cuesta MC, Gutiérrez Fernández P, et al. (2021). Ruxolitinib in severe COVID-19: results of a multicenter, prospective, single arm, open-label clinical study to investigate the efficacy and safety of ruxolitinib in patients with COVID-19 and severe acute respiratory syndrome. Rev Fac Cien Med Univ Nac Cordoba. (Among 51 hospitalized adults with COVID-19 treated with ruxolitinib or placebo added to standard of care, the mortality rate was 0% but rates of ICU admission, mechanical ventilation and duration of hospitalization were similar to those in historical controls, while ALT or AST elevations occurred in 58% on ruxolitinib vs 48% in controls).
Neubauer A, Johow J, Mack E, Burchert A, Meyn D, Kadlubiec A, Torje I, Wulf H, et al. (2021). The janus-kinase inhibitor ruxolitinib in SARS-CoV-2 induced acute respiratory distress syndrome (ARDS). Leukemia. (Among 16 adults with COVID-19 pneumonitis on mechanical ventilation treated with ruxolitinib [10 mg twice daily], the 29 day mortality was 19% and adverse events included one patient with ALT elevations).
Gatti M, Turrini E, Raschi E, Sestili P, Fimognari C. (2021). Janus kinase inhibitors and coronavirus disease (COVID)-19: rationale, clinical evidence and safety issues. Pharmaceuticals (Basel). (Review of the theoretic basis for use of JAK inhibitors in COVID-19 disease, clinical efficacy and safety of baricitinib and ruxolitinib mentions rare instances of ALT elevations and one case of drug induced liver injury).
Garcia-Horton A, Smith E, Maze D, McNamara C, Sibai H, Gupta V. (2021). Risk of hepatitis B virus reactivation in HBsAg-negative, anti-HBc-positive patients with myeloproliferative neoplasms treated with ruxolitinib. Leuk Lymphoma. (Among 58 patients with myeloproliferative neoplasms who had anti-HBc without HBsAg, only one of 20 treated with ruxolitinib developed reactivation of hepatitis B which was mild and transient [peak HBV DNA 530 IU/mL, normal ALT and bilirubin], while none of 38 anti-HBc positive patients receiving other antineoplastic therapies developed reactivation).
Duan MH, Cao XX, Chang L, Zhou DB. (2021). Risk of hepatitis B virus reactivation following ruxolitinib treatment in patients with myeloproliferative neoplasms. Hematology. (Among 224 patients with myeloproliferative neoplasms treated with ruxolitinib between 2013 and 2020, 2 of 6 HBsAg-positive patients developed reactivation of hepatitis B [both did not receive prophylaxis while the other 4 did], but none of 56 with anti-HBc without HBsAg developed reactivation despite not receiving antiviral prophylaxis).
Sjoblom M, Chtioui H, Fraga M, Stalder G, Grandoni F, Blum S. (2022). Hepatitis B reactivation during ruxolitinib treatment. Ann Hematol. (79 year old man with polycythemia vera and secondary myelofibrosis who was HBsAg negative but anti-HBc positive developed reactivation of hepatitis B with HBV DNA [19 million IU/mL], HBsAg and ALT elevations [385 U/L] but without symptoms or jaundice after 4 years of successful ruxolitinib therapy, responding to stopping chemotherapy and starting tenofovir and later able to restart ruxolitinib).
Hoisnard L, Lebrun-Vignes B, Maury S, Mahevas M, El Karoui K, Roy L, Zarour A, et al. (2022). Adverse events associated with JAK inhibitors in 126,815 reports from the WHO pharmacovigilance database. Sci Rep. (Among 126,815 individual case safety reports on ruxolitinib, tofacitinib and baricitinib made to the WHO pharmacovigilance registry, infections were most frequent including viral, fungal, bacterial and mycobacterial complications, while there was no increase in hepatobiliary reports).
Levy G, Guglielmelli P, Langmuir P, Constantinescu S. (2022). JAK inhibitors and COVID-19. J Immunother Cancer. (Review of the mechanism of action of JAK inhibitors and results of their use in severe COVID-19 infection focusing upon baricitinib; ruxolitinib has not been shown to ameliorate the course of COVID-19 in hospitalized patients whereas baricitinib has, the reasons for the difference being unclear as they both have activity against JAK1 and JAK2).
Raghuvanshi R, Bharate SB. (2022). Recent developments in the use of kinase inhibitors for management of viral infections. J Med Chem. (Review of the kinase inhibitors approved for use in the US, their mechanisms of action and possible role in inhibiting viral replication).
Han MK, Antila M, Ficker JH, Gordeev I, Guerreros A, Bernus AL, Roquilly A, et al. (2022). Ruxolitinib in addition to standard of care for the treatment of patients admitted to hospital with COVID-19 (RUXCOVID): a randomised, double-blind, placebo-controlled, phase 3 trial. Lancet Rheumatol. (Among 432 hospitalized patients with COVID-19 not on mechanical ventilation or in the ICU treated with ruxolitinib [5 mg twice daily] or placebo for 14 days, there were no differences in mortality rates with [3% vs 2%] or rates of ICU admission or mechanical ventilation in the two groups and adverse event rates were similar [65% vs 62%], as were serious adverse events [11% vs 10.5%] and ALT elevations [6% vs 4%]).

## OTHER REFERENCE LINKS

1 Recent References on Ruxolitinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ruxolitinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Ruxolitinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ruxolitinib)